# Olaratumab

## OVERVIEW

### Introduction

Olaratumab is a human monoclonal antibody to the platelet-derived growth factor (PDGF) receptor alpha and an antineoplastic agent used in the therapy of advanced soft tissue sarcoma. Olaratumab has not been linked to serum enzyme elevations during therapy or to idiosyncratic acute liver injury.

### Background

Olaratumab (oh" lar at' ue mab) is a recombinant human monoclonal IgG1 antibody to the platelet-derived growth factor receptor alpha. Signaling through PDGF receptors promotes cell proliferation and angiogenesis. Inhibition of the PDGF signaling decreases formation of new blood vessels, which plays an important role in growth and spread of cancer cells. When used in combination with other antineoplastic agents, olaratumab has been shown to extend recurrence-free survival in several forms of advanced cancer. Olaratumab was approved in the United States in 2016 for use in combination with doxorubicin for refractory, advanced soft tissue sarcoma. Olaratumab is available in solution in single use vials of 500 mg in 50 mL or 190 mg in 19 mL (10 mg/mL) under the brand name Lartruvo. The typical dose is 15 mg/kg intravenously over 60 minutes on days 1 and 8 of each 21-day cycle. Premedication with diphenhydramine and dexamethasone is recommended with the initial dose. Olaratumab is administered with doxorubicin and this combination has significant adverse side effects, including nausea and vomiting, diarrhea, fatigue, anorexia, abdominal pain, alopecia, peripheral neuropathy, neutropenia, and stomatitis. Uncommon, but potentially severe adverse events include severe infusion reactions, hypersensitivity reactions, and embryofetal toxicity.

### Hepatotoxicity

In preregistration clinical trials, serum aminotransferase elevations were no more frequent in patients receiving olaratumab and doxorubicin than in those receiving doxorubicin alone (17.5% vs 16.1%), and no patient developed elevations above 5 times ULN or required dose modification or discontinuation for liver test abnormalities. Hepatotoxicity was not listed as a cause of serious adverse events or a reason for discontinuation of olaratumab. Subsequent to its approval and more general use, olaratumab has not been implicated in published cases of clinically apparent liver injury. Olaratumab is generally given with other potent antineoplastic agents and it is often difficult to attribute serum enzyme elevations or clinically apparent liver injury to a specific agent being used.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible mechanism of liver injury caused by olaratumab is not known. It is a recombinant protein and unlikely to be inherently hepatoxic. Proteins are metabolized to small polypeptides and amino acids in many cells including hepatocytes and do not alter the activity of drug metabolizing enzymes or hepatic transporter molecules. Blocking of PDGF signaling does not seem to harm liver cells or alter hepatic function.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Olaratumab – Lartruvo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Olaratumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Olaratumab | 1024603-93-7 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 29 May 2017

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; no specific discussion of olaratumab).
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Chiorean EG, Sweeney C, Youssoufian H, Qin A, Dontabhaktuni A, Loizos N, Nippgen J, et al. A phase I study of olaratumab, an anti-platelet-derived growth factor receptor alpha (PDGFRα) monoclonal antibody, in patients with advanced solid tumors. Cancer Chemother Pharmacol 2014; 73: 595-604. (Among 19 patients with advanced solid tumors treated with one of 5 regimens of olaratumab, there were no objective responses and the most common adverse events were fatigue, constipation, diarrhea and fever; no mention of ALT elevations or hepatotoxicity). 24452395
Doi T, Ma Y, Dontabhaktuni A, Nippgen C, Nippgen J, Ohtsu A. Phase I study of olaratumab in Japanese patients with advanced solid tumors. Cancer Sci 2014; 105: 862-9. (Among 16 patients with various advanced tumors treated with olaratumab [10, 15 or 20 mg/kg], adverse events included proteinuria in 25% and AST elevations in 12%, but none required dose modification or discontinuation). 24816152
Tap WD, Jones RL, Van Tine BA, Chmielowski B, Elias AD, Adkins D, Agulnik M, et al. Olaratumab and doxorubicin versus doxorubicin alone for treatment of soft-tissue sarcoma: an open-label phase 1b and randomised phase 2 trial. Lancet 2016; 388 (10043): 488-97. (Among 133 patients treated with doxorubicin, addition of olaratumab [15 mg/kg] on days 1 and 8 of 21-day cycles increased the objective response rate [18% vs 12%] and overall survival [median 26.5 vs 14.7 months]; adverse events were more frequent with addition of olaratumab and included neutropenia [38% vs 35%], mucositis [53% vs 35%], nausea [73% vs 52%], vomiting [45% vs 18%], and diarrhea [34% vs 23%]; no mention of ALT elevations or hepatotoxicity). 27291997
van der Graaf WT. Olaratumab in soft-tissue sarcomas. Lancet 2016; 388 (10043): 442-4. (Editorial accompanying Tap [2016] discussing the promise of PDGF pathway inhibition for soft tissue sarcoma). 27291995
Wagner AJ, Kindler H, Gelderblom H, Schöffski P, Bauer S, Hohenberger P, Kopp HG, et al. A phase II study of a human anti-PDGFRα monoclonal antibody (olaratumab, IMC-3G3) in previously treated patients with unresectable and/or metastatic gastrointestinal stromal tumors. Ann Oncol 2017; 28 (3): 541-6. (Among 21 patients with refractory metastatic gastrointestinal stromal tumors treated with olaratumab [20 mg/kg every 2 weeks], no objective responses were seen and side effects included fatigue [38%], nausea [19%], peripheral edema [14%] and single instances of syncope and hypertension; no mention of ALT elevations or hepatotoxicity).
Klug LR, Heinrich MC. PDGFRA antibody for soft tissue sarcoma. Cell 2017; 168: 555. (Commentary on PDGF signaling and the possible role of its inhibition in treatment of soft tissue sarcoma). 28187274

## OTHER REFERENCE LINKS

1. Recent References on Olaratumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Olaratumab/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Olaratumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Olaratumab)